# Eszopiclone

## OVERVIEW

### Introduction

Eszopiclone is a benzodiazepine receptor agonist that is used for the treatment of insomnia. Eszopiclone has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Eszopiclone (es zoe' pi klone) is a non-benzodiazepine, benzodiazepine receptor agonist of the cyclopyrrolone class that acts by binding to the benzodiazepine (BZ) site on the GABA receptor complex, causing neural inhibition and helping to induce sleep. Eszopiclone has selectivity for certain BZ receptor subtypes, and does not have the neuromuscular relaxation or anticonvulsant effects of the standard benzodiazepines. Eszopiclone has a relatively short half life and rapid onset of action. In multiple placebo controlled trials, eszopiclone was shown to decrease the latency to onset of sleep and improve perceived sleep quality, with few next day residual effects and minimal evidence of rebound insomnia after withdrawal. Eszopiclone is the S-isomer of zopiclone that has been available in other countries for more than 20 years. Eszopiclone was approved for use in the United States in 2004 for the treatment of insomnia and remains in common use. Eszopiclone is available in 1, 2 and 3 mg tablets generically and under the brand name Lunesta. The recommended dose is 1 to 3 mg taken orally immediately before bedtime. Like the other benzodiazepine receptor agonists, eszopiclone is classified as a Schedule IV controlled substance (low potential for abuse and limited physical or psychological dependence). Side effects are uncommon, usually mild and may include unpleasant taste (bitter), headache, nausea, dizziness, dry mouth and drowsiness.

### Hepatotoxicity

In multiple premarketing randomized controlled trials, eszopiclone was not associated with an increased rate of serum enzyme elevations in comparison to placebo therapy, and no instance of clinically apparent liver injury was reported. Since its approval and widescale use, eszopiclone has not been implicated in causing clinically apparent liver disease, although hepatitis and liver injury are listed as a rare adverse reactions in the product label. Eszopiclone is metabolized in the liver by the cytochrome P450 system (predominantly CYP 3A4 and 2E1). Nevertheless, drug-drug interactions appear to be uncommon. Thus, eszopiclone induced liver injury must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Sedatives and Hypnotics

Other Drugs in the Subclass, Benzodiazepine Receptor Agonists: Zaleplon, Zolpidem

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eszopiclone – Generic, Lunesta®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eszopiclone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eszopiclone | 138729-47-2 | C17-H17-Cl-N6-O3 | Eszopiclone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2018

Zimmerman HJ. Anxiolytic agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of hepatotoxicity published in 1999 discusses benzodiazepines and minor tranquilizers; "In general, the hepatotoxic potential of this widely used group of compounds seems low").
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian, all of which have been linked to rare cases of liver injury; no discussion of eszopiclone).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Roblin X, Boudemaghe T, Paris F, Pellissier L, Le Gall S. [Unexplained increase in aminotransferases and obstructive sleep apnea syndrome]. Gastroenterol Clin Biol 2002; 26: 416-7. French. (45 year old woman found to have minor serum ALT elevations [1.5-3 times ULN] without jaundice or symptoms while taking zolpidem, which improved on stopping, but which were subsequently shown to be due to severe sleep apnea). 12070418
Terzano MG, Rossi M, Palomba V, Smerieri A, Parrino L. New drugs for insomnia: comparative tolerability of zopiclone, zolpidem and zaleplon. Drug Saf 2003; 26: 261-82. (Comparison of adverse events and tolerability of three new drugs for insomnia, focusing upon CNS symptoms such as headache, drowsiness and fatigue; mentions rare observations suggestive of hepatotoxicity of zolpidem [Karsenti 1999]). 12608888
Drover DR. Comparative pharmacokinetics and pharmacodynamics of short-acting hypnosedatives: zaleplon, zolpidem and zopiclone. Clin Pharmacokinet 2004; 43: 227-38. (Review of mechanism of action, pharmacology, efficacy and adverse effects of 3 non-benzodiazepine hypnotic agents: zaleplon, zolpidem and zopiclone). 15005637
Zammit GK, McNabb LJ, Caron J, Amato DA, Roth T. Efficacy and safety of eszopiclone across 6-weeks of treatment for primary insomnia. Curr Med Res Opin 2004; 20: 1979-91. (Controlled trial of 44 days of two doses of eszopiclone vs placebo in 308 patients with insomnia; adverse events were uncommon, but included headache, dry mouth and drowsiness; "there was no evidence of drug-related effects on...laboratory...measures"). 15701215
Rosenberg R, Caron J, Roth T, Amato D. An assessment of the efficacy and safety of eszopiclone in the treatment of transient insomnia in healthy adults. Sleep Med 2005; 6: 15-22. (Controlled trial of 4 doses of eszopiclone vs placebo given for one night in 436 patients; most common side effect was unpleasant taste and changes in laboratory test results "were similar across all treatment groups, including placebo"). 15680290
Eszopiclone (Lunesta), a new hypnotic. Med Lett Drugs Ther 2005; 47 (1203): 17-9. (Concise summary of mechanism of action, pharmacokinetics, efficacy and safety of eszopiclone for insomnia published shortly after its approval in the US; no mention of change in ALT levels or hepatotoxicity). 15767972
Roth T, Walsh JK, Krystal A, Wessel T, Roehrs TA. An evaluation of the efficacy and safety of eszopiclone over 12 months in patients with chronic primary insomnia. Sleep Med 2005; 6: 487-95. (Results of open label extended use [12 months] study of eszopiclone in 382 patients who had participated in a placebo controlled trial; eszopiclone was well tolerated and there were "no systematic differences" in blood chemistry results during the open label period). 16230048
Najib J. Eszopiclone, a nonbenzodiazepine sedative-hypnotic agent for the treatment of transient and chronic insomnia. Clin Ther 2006; 28: 491-516. (Systematic review of efficacy and safety of eszopiclone for treatment of insomnia; in 6 large controlled trials involving ~1550 patients, adverse events were uncommon and mild and there were no laboratory test abnormalities identified or mention of clinically apparent liver injury). 16750462
Morin AK, Willett K. The role of eszopiclone in the treatment of insomnia. Adv Ther 2009; 26: 500-18. (Systematic review of efficacy and safety of eszopiclone in treatment of insomnia; side effects occurring more often than with placebo included unpleasant [bitter] taste, headache, somnolence, dizziness, and dry mouth; no mention of changes in ALT levels or hepatotoxicity). 19513631
Ancoli-Israel S, Krystal AD, McCall WV, Schaefer K, Wilson A, Claus R, Rubens R, Roth T. A 12-week, randomized, double-blind, placebo-controlled study evaluating the effect of eszopiclone 2 mg on sleep/wake function in older adults with primary and comorbid insomnia. Sleep 2010; 33: 225-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2020175406) (Controlled trial of 12 week course of eszopiclone vs placebo in 288 elderly patients with insomnia; the only adverse event that was more frequent with eszopiclone was unpleasant taste [12.4% vs 1.5%]; one treated patient developed cholecystitis which was considered unrelated to therapy).
Owen RT. Eszopiclone: an update on its use in insomnia. Drugs Today (Barc) 2011; 47: 263-75. (Review of mechanism of action, pharmacology, efficacy and safety of eszopiclone for insomnia; side effects [except unpleasant taste] are uncommon and no more common with eszopiclone than placebo; no mention of changes in ALT levels or hepatotoxicity). 21573250
Drugs for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guidelines for therapy of insomnia; mentions that benzodiazepine receptor agonists such as eszopiclone, benzodiazepines, ramelteon and low doses of doxepin are effective and generally safe; in discussing adverse events, no mention is made of ALT elevations or hepatotoxicity of any of the recommended agents). 22777275
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a sleeping aid, despite the fact that zopiclone and zolpidem are among the 25 most commonly prescribed drugs in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to eszopiclone or other sedatives or sleeping aids). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to agents active in the central nervous system, but none were due to eszopliclone or other sedatives or sleeping aids). 25754159
Drugs for insomnia. Med Lett Drugs Ther 2015; 57 (1472): 95-8. (Concise review of the mechanism of action, efficacy, safety and costs of drugs for insomnia including benzodiazepine receptor agonists including eszopliclone as well as benzodiazepines, melatonin receptor agonists, orexin receptor antagonists and other agents including nonprescription and herbal products). 26147892

## OTHER REFERENCE LINKS

1. Recent References on Eszopiclone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Eszopiclone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eszopiclone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eszopiclone)